# Didanosine

## OVERVIEW

### Introduction

Didanosine is a purine nucleoside analogue and reverse transcriptase inhibitor that was previously widely used in combination with other agents in the therapy of human immunodeficiency virus (HIV) infection and the acquired immunodeficiency syndromes (AIDS). Didanosine therapy is associated with an appreciable rate of serum enzyme elevations during therapy, and it is a well established cause of clinically apparent acute liver injury as well as mitochondrial injury to many organs which can be associated with severe liver injury, lactic acidosis and hepatic failure. Finally, long term therapy with didanosine can cause noncirrhotic portal hypertension due to hepatoportal sclerosis and nodular regenerative hyperplasia. Because of its many, potentially severe adverse events, didanosine has been largely replaced by better tolerated agents and is now rarely used.

### Background

Didanosine (dye dan' oh seen) is a synthetic nucleoside analogue of inosine (2’,3’-dideoxyinosine, ddI) that is converted intracellularly to dideoxyadenosine. Didanosine inhibits HIV replication by competing with naturally occurring adenosine for incorporation into the growing viral DNA chain, causing inhibition of the viral polymerase and chain termination. Didanosine is a first generation antiretroviral agent and was approved for use in the United States in 1991. It was widely used for many years, but has now been replaced by better tolerated agents. Because of its relatively low cost, didanosine continues to be used in developing nations. Didanosine is indicated for the treatment of HIV infection in combination with other antiretroviral agents. Didanosine is available in generic forms and under the trade names Videx in 100 mg tablets and as extended release capsules of 125, 200, 250, and 400 mg, as well as in an oral powder for suspension (10 mg/mL). The recommended dose in adults is 250 to 400 mg orally once daily. Common side effects include rash, abdominal pain, diarrhea, nausea and vomiting, asthenia, headache, and fever. Uncommon but potentially severe adverse events include pancreatitis, hepatotoxicity, peripheral neuropathy, immune reconstitution syndrome, lipodystrophy and severe hypersensitivity reactions.

### Hepatotoxicity

Mild and transient elevations in liver enzymes occur in up to 9% of patients on didanosine, but these are generally asymptomatic and self-limited. Clinically apparent hepatotoxicity is uncommon, but well described. Several forms of liver injury have been associated with didanosine use: acute idiosyncratic liver injury, lactic acidosis with steatosis and hepatic dysfunction (LASH), and noncirrhotic portal hypertension due to nodular regenerative hyperplasia or hepatoportal sclerosis.

Rare instances of acute, seemingly idiosyncratic liver injury due to didanosine have been described, particularly in children. The injury arises within a few weeks of starting therapy and is associated with hepatocellular pattern of serum enzymes (Case 3). Immunoallergic features (rash, fever and eosinophilia) may occur, but are not prominent and autoantibodies are generally not present. Recovery is rapid with stopping didanosine, but the injury can be severe and lead to acute liver failure. This form of didanosine injury is rare and resembles the idiosyncratic acute hepatitis-like injury that occurs with many medications.

The second pattern of injury due to didanosine is more common and is characterized by development of marked lactic acidosis, microvesicular steatosis, and hepatic synthetic dysfunction (LASH). This form of liver injury typically arises after at least two months of therapy and is preceded by nonspecific prodromal symptoms of anorexia, nausea, vomiting, diarrhea, and weakness which is followed by dyspnea, jaundice and confusion. Lactic acidosis usually accompanies the hepatic injury and may be the predominant clinical feature. Jaundice arises late and serum enzymes are unusually only mildly or moderated elevated, the pattern being mixed or actually cholestatic. Pancreatitis, myopathy and neuropathy may also occur. This distinctive form of hepatotoxicity associated with didanosine can be rapidly fatal (Case 1), but is potentially reversible with intensive support and early withdrawal of therapy (Case 2). Preexisting liver injury, female sex, older age, obesity, alcohol use and concurrent therapy with stavudine, ribavirin or tenofovir appear to increase the risk of this syndrome. LASH is most commonly associated with stavudine therapy, but can also occur with zidovudine, fialuridine, intravenous tetracycline, linezolid and aspirin (Reye syndrome).

A final form of didanosine associated liver injury is noncirrhotic portal hypertension due to nodular regenerative hyperplasia or hepatoportal sclerosis (Case 4). This chronic form of liver injury due to didanosine generally arises after several years of therapy. Patients usually present with signs of portal hypertension and advanced liver disease, ascites, variceal hemorrhage, muscle wasting and weakness with no obvious cause (absence of hepatitis B or C and no history of alcoholism). Serum enzymes are only modestly elevated and bilirubin levels can be normal. Platelet counts tend to be low and a fall of platelet count can be a useful surrogate marker for the development of portal hypertension. These patients have typically been on multiple antiretroviral agents and the attribution of injury to didanosine cannot always be made. The clinical presentation can be after didanosine has been discontinued. Stavudine and zidovudine have also been implicated as have other nucleoside analogues such as azathioprine, mercaptopurine and thioguanine. Major risk factors associated with this complication include duration of didanosine use, low CD4 cell counts and concurrent use of stavudine. Liver biopsy shows the absence of cirrhosis and changes of nodular regenerative hyperplasia or hepatoportal sclerosis or both. Hepatic venous pressure gradients are usually elevated, but probably underestimate the degree of portal hypertension because of its presinusoidal nature. Similarly, noninvasive tests for hepatic fibrosis, such a transient elastography, are usually abnormal but not to the degree that is usually associated with the portal hypertension that occurs with cirrhosis.

Interestingly, a high proportion of patients who develop noncirrhotic portal hypertension have an underlying thrombophilic condition such as protein S or protein C deficiency and are prone to develop portal vein thrombosis which can be the cause of acute decompensation.

Likelihood score: A (well known cause of both acute and chronic forms of clinically apparent liver injury).

### Mechanism of Injury

The clinically apparent hepatotoxicity from didanosine associated with lactic acidosis and hepatic steatosis is probably a direct effect of the nucleoside due to widespread injury or depletion of mitochondria. In vitro, didanosine has been found to inhibit the gamma polymerase responsible for replication of mitochondria and maintenance of mitochondrial function and numbers. After several months of therapy, mitochondrial numbers can fall to critical levels. The mitochondrial failure in hepatocytes leads to inability to metabolize lactic acid and free fatty acids and to support usual hepatic synthetic and excretory function. Mitochondrial injury to other tissue can lead to pancreatitis, myopathy and neuropathy.

The pathogenesis of the other forms of liver injury from didanosine are not well defined. Nodular regenerative hyperplasia and hepatoportal sclerosis are suspected to be caused by chronic vascular injury to small portal vein radicles and may be another manifestation of mitochondrial depletion and injury. The idiosyncratic hepatitis associated with didanosine may be immunologically mediated and is probably unrelated to mitochondrial injury.

Didanosine is chiral molecule that can exist in left (L or levorotatory) and right (D or dextrotatory) forms. Didanosine is a synthetic nucleoside analogue and is a racemic mixture of equal amounts of the D and L forms. In nature, however, only the D-forms of nucleosides are made and used to synthesize DNA. Mitochondrial injury appears to be more frequent with the D- rather than L- enantiomers of nucleoside analogues, and the greater safety of L-isoforms has been used to produce safer and better tolerated antiviral agents such as lamivudine (L-3TC), telbivudine (L-thymidine) and clevudine (L-FMAU).

### Outcome and Management

The severity of liver injury due to didanosine ranges from mild and transient enzyme elevations to clinically apparent hepatitis and to severe hepatic steatosis with intractable lactic acidosis and hepatic failure. Cases of acute hepatic failure with centrolobular necrosis have also been reported with didanosine, largely in children. Long term therapy is associated with noncirrhotic portal hypertension, but there have also been isolated reports of cirrhosis after nucleoside analogue induced severe hepatic steatosis and lactic acidosis. Didanosine has not been associated with vanishing bile duct syndrome. Rechallenge can lead to recurrence of mitochondrial dysfunction and should be avoided. Persons who develop didanosine hepatotoxicity should avoid use of other dideoxynucleosides such as stavudine and zalcitabine, and caution should be used in use of zidovudine. Various interventions have been used in attempts to treat the severe lactic acidosis and hepatic steatosis induced by nucleoside analogues. These interventions have included bicarbonate infusions, thiamine, l-carnitidine as well as renal dialysis and mechanical ventilation. Intravenous 20% glucose decreases lactic acid levels in some patients. Liver transplantation has reversed lactic acidosis in the rare patient that has undergone emergency transplantation, but this option is rarely practical.

Nodular regenerative hyperplasia from long term therapy with didanosine, stavudine or zidovudine should be treated conservatively with management of the signs and symptoms of portal hypertension. Stavudine (and all first generation nucleoside analogues) should be discontinued and the patient switched to other antiretroviral agents. Typically, nodular regenerative hyperplasia improves after drug withdrawal, and symptoms, signs and abnormal liver tests may ultimately resolve. The long term consequences of nodular regenerative hyperplasia after drug withdrawal is uncertain and not well defined. Unrelated acute severe medical conditions such as pneumonia or sepsis can cause reappearance of signs and symptoms of portal hypertension (ascites, variceal hemorrhage) and evidence of hepatic decompensation (weakness, jaundice, and hepatic encephalopathy).

Drug Class: Antiviral Agents, Antiretroviral Agents

Other Drugs in the Subclass, Nucleoside Analogues: Abacavir, Adefovir, Emtricitabine, Entecavir, Lamivudine, Stavudine, Telbivudine, Tenofovir, Zidovudine

## CASE REPORTS

### Case 1. Lactic acidosis, marked hepatic steatosis and liver failure due to didanosine.(1)

A 45 year old man with HIV infection and AIDS on zidovudine for 7 months and didanosine for 4 months developed nausea, vomiting, diarrhea, abdominal pain and shortness of breath. Blood testing showed severe metabolic acidosis with a serum bicarbonate of 3 mmol/L and lactate 43 mmol/L. Serum bilirubin and enzymes were only modestly elevated (Table). The patient had no history of liver or biliary tract disease or alcohol abuse. Tests for hepatitis A, B, C, D and E were negative. Despite intensive support, mechanical ventilation, bicarbonate therapy, and renal dialysis, he developed progressive hepatic and multiorgan failure and died 7 days after admission. Transjugular liver biopsy showed diffuse microvesicular steatosis with moderate cholestasis, but little hepatocellular necrosis, parenchymal inflammation or fibrosis.

#### Key Points

Medication: | Didanosine (7.5 mg/kg/day) for 13 weeks
Pattern: | Mixed; mild enzyme elevations (R=2.3)
Severity: | 5+ (fatal)
Latency: | 13 weeks
Recovery: | None
Other medications: | Zidovudine, pentamidine

#### Laboratory Values

Time After Starting | Time After Stopping | AST (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Comments
13 weeks | | 146 | 146 | 1.6 | pH=7.12; Lactate high
Antiretroviral agents discontinued
| 4 days | 293 | 85 | 4.4
14 weeks | 7 days | 287 | | 5.3 | Death
Normal Values | | <46 | <110 | <1.2

#### Comment

Typical course of lactic acidosis due to nucleoside analogue therapy with a 1 to 2 week prodromal period of nausea, diarrhea, and anorexia followed by progressive dyspnea and confusion. The injury is typically “delayed” requiring months of therapy before there is significant decline in mitochondrial function or numbers. Despite severe hepatic synthetic failure, serum enzymes are usually only modestly elevated and serum bilirubin elevations occur late. The lactic acidosis of nucleoside analogue therapy appears to respond transiently to infusions of 20% glucose and can be reversed by emergency liver transplantation, but this is rarely feasible.

### Case 2. Lactic acidosis arising during therapy with didanosine after addition of tenofovir.(2)

A 45 year old woman with HIV infection and chronic hepatitis C had been treated with a combination of didanosine, stavudine, and tenofovir for 8 weeks when she developed vomiting, abdominal pain, and obtundation. Nevirapine had been stopped and tenofovir added to a long term regimen of stavudine and didanosine 8 weeks before admission because of minor serum enzymes elevations which then returned to initial values. On admission, she was jaundiced and disoriented and had tender hepatomegaly. Serum bilirubin was 12.6 mg/dL, ALT 157 U/L, and an INR was 2.1. She had lactic acidosis with blood pH of 7.24 and lactate levels of 16.4 mmol/L. Imaging of the liver suggested fatty infiltration of the liver. Antiretrovirals were discontinued, but the lactic acidosis and hepatic failure worsened, and she died two days after admission.

#### Key Points

Medication: | Didanosine, stavudine, tenofovir
Pattern: | Mild serum ALT elevations
Severity: | 5+ (fatal)
Latency: | 8 weeks
Recovery: | None
Other medications: | Nevirapine, 8 weeks previously

#### Comment

Acute microvesicular hepatic steatosis with liver failure and lactic acidosis is a syndrome associated with several medications including the nucleoside analogues, particularly didanosine, stavudine and zidovudine. A similar syndrome occurs with intravenous tetracycline, aspirin (Reyes syndrome) and valproate, but the timing and course is different for those agents (shorter latency period), probably because they directly affect function of mitochondria rather than by causing functional failure by inhibition of mitochondrial replication. Mitochondria have a half-life of several weeks, so that inhibition of mitochondrial replication would be expected to lead to severe dysfunction (mitochondrial failure) after 2 to 3 months. Both didanosine and stavudine have been linked to many cases of hepatic steatosis and lactic acidosis, and the addition of tenofovir appears to increase the risk of the complication. By itself, tenofovir has not been associated with this syndrome. Other risk factors for hepatic steatosis with lactic acidosis include presence of underlying liver disease (such as hepatitis C), female sex, older age, obesity and alcohol use.

### Case 3. Severe liver toxicity attributed to didanosine therapy.(3)

A 36 year old man with long standing HIV infection who had been treated with multiple antiretroviral regimens and who was on long term stavudine therapy was started on didanosine, nelfinavir and nevirapine and developed nausea and liver test abnormalities 3 months later [bilirubin 1.5 mg/dL, ALT 217 U/L, Alk P normal]. Antiretroviral therapy was stopped and he recovered rapidly. Two months later, all liver tests were normal and he was restarted on didanosine, stavudine, and hydroxyurea. Three months later, he again developed nausea, right upper quadrant pain and jaundice. Serum bilirubin was 14.5 mg/dL, ALT 241 U/L, and alkaline phosphatase 121 U/L, with prolongation of the prothrombin time and decrease in serum albumin to 2.1 g/dL. Lactic acid levels were not provided, but serum bicarbonate was normal. Tests for hepatitis A, B and C were negative, and he had no history of alcohol abuse. The antiretroviral agents were stopped. A liver biopsy showed prominent ballooning degeneration, hepatocyte necrosis, chronic inflammatory infiltrates and cholestasis without steatosis. He improved slowly. Four months later the he was anicteric and asymptomatic, and eight months later serum enzyme levels were normal and an antiretroviral regimen of abacavir, efavirenz and nelfinavir was started without further evidence of hepatotoxicity.

#### Key Points

Medication: | Didanosine
Pattern: | Mixed
Severity: | 4+ (jaundice and prothrombin time prolongation)
Latency: | 3 months
Recovery: | Several months
Other medications: | Stavudine, hydroxyurea, trimethoprim-sulfamethoxazole

#### Comment

This patient developed a severe hepatitis 3 months after adding didanosine to an antiretroviral regimen that included stavudine. The clinical features were somewhat different from those typical of hepatic steatosis and lactic acidosis due to mitochondrial injury. Similar cases of severe acute hepatitis due to didanosine have been reported in children. The pathogenesis is unknown, but is likely to be idiosyncratic.

### Case 4. Noncirrhotic portal hypertension caused by long-term didanosine therapy.(4)

A 10 year old girl with vertically acquired HIV infection developed progressive enlargement of the spleen of unknown cause. She had been on antiretroviral therapy for 8 years which had consisted of didanosine, tenofovir and lopinavir/ritonavir for the previous 7 years. The HIV infection was well controlled with a CD4+ lymphocyte count of 425 cells/µL and undetectable levels of HIV RNA (<37 copies/mL). The platelet count was 154,000/µL, INR 1.28, bilirubin 0.8 mg/dL, ALT 48 U/L, AST 52 U/L, Alk P 231 U/L, GGT 35 U/L and albumin 3.5 g/dL. Tests for hepatitis B and C were negative as were autoantibodies. There was mild decreases in protein C (49% of normal) and free protein S antigen (60%), but no other evidence of genetic hypercoagulability (such as Factor V Leiden or prothrombin genetic mutations). Imaging showed diffuse inhomogeneity of the liver texture and nodularity, splenomegaly, mild ascites and patency of the portal and hepatic veins, but presence of venous collaterals. Upper endoscopy revealed esophageal varices. Hepatic venous pressure gradient measurements were normal (3.8 mm Hg) and liver biopsy showed hepatoportal sclerosis with absence of portal vein branches in portal tracts, mild-to-moderate steatosis, focal sinusoidal fibrosis and central venosclerosis. Thus, she was believed to have noncirrhotic portal hypertension and hepatoportal sclerosis, possibly due to long term didanosine therapy. Her antiretroviral regimen was changed to darunavir/ritonavir and etravirine. Serum HIV RNA levels remained undetectable and liver tests were stable. However, within a year of diagnosis of noncirrhotic portal hypertension she had an esophageal variceal bleed for which she underwent band ligation and therapy with propranolol.

#### Key Points

Medication: | Didanosine for 7 years
Pattern: | (R=2.3)
Severity: | 4+ (severe, portal hypertension)
Latency: | 7 years
Recovery: | None
Other medications: | Tenofovir, lopinavir, ritonavir, iron

#### Comment

This case demonstrates a fairly typical presentation of noncirrhotic portal hypertension in a patient with HIV infection on long term didanosine therapy. Concurrent use of tenofovir may have predisposed to this complication. Routine liver tests were only mildly abnormal, but the platelet count was low. The unusual features were the patient's age and lack of other complications of HIV. These features, however, show that this complication is independent of serious comorbidities of HIV, HBV or HCV and occurs in patients with excellent control of the underlying HIV infection. As described, the liver histology was most compatible with hepatoportal sclerosis, but features of nodular regeneration were not commented upon and they are often subtle and easy to miss. The pathogenesis of the liver injury that causes these two histological patterns is not well understood, but appears to be related to portal venopathy with loss of small portal radicles with subsequent portal fibrosis or nodular regeneration or both. Venous thromboses in the portal system are also frequent as are mild-to-moderate decreases in protein C and S, which can result in portal vein thrombosis. Whether the underlying pathogenesis is an inflammatory venopathy, mitochondrial damage to portal endothelial cells or microthromboses in the portal system (or all three) is unclear. The prognosis of noncirrhotic portal hypertension is guarded, even with prompt discontinuation of didanosine and avoidance of other nucleoside analogues, slowly progressive portal hypertension and its complications can occur. Within a year, this child developed a variceal hemorrhage. Because of the multiplicity of complications of long term didanosine therapy, it is now rarely used in developed countries. Patients who are on didanosine should be monitored for complications and serial platelet counts may represent the most convenient surrogate means of early detection of portal hypertension. A decrease of more than 14,000 platelets/µL per year (even while in the normal range) is suggestive of the development of mild portal hypertension.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Didanosine – Generic, Videx®

DRUG CLASS

Antiviral Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=didanosine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Didanosine | 69655-05-6 | C10-H12-N4-O3

## CITED REFERENCES

1 Bissuel F, Bruneel F, Habersetzer F, Chassard D, Cotte L, Chevallier M, Bernuau J, et al. (1994). Fulminant hepatitis with severe lactate acidosis in HIV-infected patients on didanosine therapy. J Intern Med.
2 Rivas P, Polo J, de Górgolas M, Fernández-Guerrero ML. (2003). Drug points: Fatal lactic acidosis associated with tenofovir. BMJ.
3 Ware AJ, Berggren RA, Taylor WE. (2000). Didanosine-induced hepatitis. Am J Gastroenterol.
4 Giacomet V, Viganò A, Penagini F, Manfredini V, Maconi G, Camozzi M, Zuccotti GV. (2012). Splenomegaly and variceal bleeding in a ten-year-old HIV-infected girl with noncirrhotic portal hypertension. Pediatr Infect Dis J.

## ANNOTATED BIBLIOGRAPHY

References updated: 25 June 2020

Abbreviations used: AIDS, acquired immune deficiency syndrome; HBV, hepatitis B virus; HCV, hepatitis C virus; HIV, human immunodeficiency virus; HPA, hepatoportal sclerosis; HVPG, hepatic venous pressure gradient; mt, mitochondrial; NASH, nonalcoholic steatohepatitis; NCPH, noncirrhotic portal hypertension; NRH, nodular regenerative hyperplasia; TE, transient elastography.

Núñez M. Hepatic toxicity of antiviral agents. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 505-18. (Review of hepatotoxicity of antiviral agents including didanosine).
Flexner C. Antiretroviral agents and treatment of HIV infection. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1137-58. (Textbook of pharmacology and therapeutics).
National Institutes of Health. http://aidsinfo.nih.gov/guidelines. (Clinical guidelines on the use of antiretroviral agents in HIV-1 infected adults, adolescents and children).
Cooley TP, Kunches LM, Saunders CA, Perkins CJ, Kelley SL, McLaren C, McCaffrey RP, et al. (1990). Treatment of AIDS and AIDS-related complex with 2',3'-dideoxyinosine given once daily. Rev Infect Dis. (Phase 1 trial of didanosine [6 dose regimens] in 36 patients with AIDS for up to 65 weeks; 6 [17%] had ALT elevations requiring dose reduction or interruption, not all attributable to drug).
Lai KK, Gang DL, Zawacki JK, Cooley TP. (1991). Fulminant hepatic failure associated with 2',3'-dideoxyinosine (ddI). Ann Intern Med. (36 year old man with AIDS developed nausea and weakness after 15 weeks of didanosine therapy [bilirubin 5.3 mg/dL, ALT 263 U/L, Alk P 90 U/L], with progressive lactic acidosis and hepatic failure, autopsy showing large liver [2550 g], marked cholestasis and microvesicular fat).
Kahn JO, Lagakos SW, Richman DD, Cross A, Pettinelli C, Liou SH, Brown M, et al. (1992). A controlled trial comparing continued zidovudine with didanosine in human immunodeficiency virus infection. The NIAID AIDS Clinical Trials Group. N Engl J Med. (913 patients with HIV infection on zidovudine were randomized to switch to didanosine [500 or 750 mg/day] or continue zidovudine; pancreatitis occurred in 7-13% of didanosine [2 fatalities], but only 3% of zidovudine treated patients; no mention of ALT levels of hepatotoxicity).
Freiman JP, Helfert KE, Hamrell MR, Stein DS. (1993). Hepatomegaly with severe steatosis in HIV-seropositive patients. AIDS. (Reports of 6 fatal and 2 nonfatal cases of hepatomegaly and steatosis in patients with HIV on zidovudine for 3-12 months).
Chattha G, Arieff AI, Cumings G, Tierney LM. (1993). Lactic acidosis complicating the acquired immunodeficiency syndrome. Ann Intern Med. (Report of 7 patients with HIV infection who developed lactic acidosis of unknown cause, presenting with nausea, anorexia and weight loss followed by dyspnea, stupor and death [in 4]; 4 on zidovudine, 1 ganciclovir and 1 clofazimine; initial arterial pH 7.09-7.27, lactate 10.4-17.4 mmol/L).
McKenzie R, Fried MW, Sallie R, Conjeevaram H, Di Bisceglie AM, Park Y, Savarese B, et al. (1995). Hepatic failure and lactic acidosis due to fialuridine (FIAU), an investigational nucleoside analogue for chronic hepatitis B. N Engl J Med. (Description of syndrome of lactic acidosis, hepatic failure and pancreatitis arising after 8-11 weeks of fialuridine treatment in 15 patients with chronic hepatitis B; among 7 patients affected, 5 died of intractable lactic acidosis and 2 survived, but required emergency liver transplantation).
Lewis W, Dalakas MC. (1995). Mitochondrial toxicity of antiviral drugs. Nat Med. (Review of mechanisms for mitochondrial injury by nucleoside analogues including inhibition of mitochondrial DNA polymerase gamma).
Styrt B, Freiman JP. (1995). Hepatotoxicity of antiviral agents. Gastroenterol Clin North Am. (Early review of liver toxicity of antiviral agents; covering the first four nucleoside analogues used for HIV infection: zidovudine, didanosine, zalcitabine and stavudine).
Bissuel F, Bruneel F, Habersetzer F, Chassard D, Cotte L, Chevallier M, Bernuau J, et al. (1994). Fulminant hepatitis with severe lactate acidosis in HIV-infected patients on didanosine therapy. J Intern Med. (Two cases of fatal acute liver failure with lactic acidosis and microvesicular fatty liver in HIV-positive patients treated with didanosine for 3-4 months with initial bilirubin 1.6 and 1.1 mg/dL, ALT 146 and 40 U/L, Alk P 146 and 151 U/L; liver histology showed diffuse microvesicular fat and mild cholestasis without fibrosis or hepatocellular necrosis: Case 1).
Lacaille F, Ortigao MB. (1995). Debré, Rouzioux C, Brousse N, Blanche S. Hepatic toxicity associated with 2.3.-dideoxyinosine in children with AIDS. J Pediatr Gastroenterol Nutr. (Among 34 children in a trial of didanosine [120 or 270 mg/m^2^ daily] for HIV infection, 2 developed acute liver failure after 2 and 18 months of therapy with ALT 1320 and 1440 U/L and severe centrolobular necrosis; 4 others had marked Alk P elevations of 1113-6930 U/L 5-12 months after starting didanosine, improving with stopping).
Brinkman K, ter Hofstede HJ, Burger DM, Smeitink JAM, Koopmans PP. (1998). Adverse effects of reverse transcriptase inhibitors: mitochondrial toxicity as a common pathway. AIDS. (Review of mitochondrial function and role of mitochondrial toxicity or depletion in the adverse side effects of nucleoside analogues).
Finkle HI. (1999). Hepatic mitochondrial toxicity from nucleoside analog therapy. Arch Pathol Lab Med. (42 year old man with HIV infection developed lactic acidosis on combination therapy with stavudine and didanosine [ALT 73 U/L], autopsy showing microvesicular steatosis).
Allaouchiche B, Duflo F, Cotte L, Mathon L, Chassard D. (1999). Acute pancreatitis with severe lactic acidosis in an HIV-infected patient on didanosine therapy. J Antimicrob Chemother. (58 year old man with HIV infection developed abdominal pain and amylase elevations [1059 U/L] and jaundice after treatment with didanosine, stavudine and indinavir [bilirubin 7.3 mg/dL, ALT 75 U/L, Alk P 107 U/L, lactate 13 mmol/L], resolving within 3 weeks of stopping).
Frippiat F, Derue G, Heller F, Honore P, Moreau M, Vandercam B. (2000). Acute pancreatitis associated with severe lactic acidosis in human immunodeficiency virus-infected patients receiving triple therapy. J Antimicrob Chemother. (Letter in response to Allaouchiche et al. suggesting that stavudine may have been the cause or contributed to the mitochondrial toxicity and pancreatitis).
Bleeker-Rovers CP, Kadir S, van Leusen R, Richter C. (2000). Hepatic steatosis and lactic acidosis caused by stavudine in an HIV-infected patient. Neth J Med. (45 year old man with HIV developed nausea and abdominal pain after 2 years of didanosine and 3 months of stavudine therapy [bilirubin 14.0 mg/dL, ALT 300 U/L, Alk P 400 U/L, no obvious acidosis], resolving slowly stopping and having recurrent rise in lactate within one week of restarting [9.1 mmol/L]).
ter Hofstede HJ, de Marie S, Foudraine NA, Danner SA, Brinkman K. (2000). Clinical features and risk factors of lactic acidosis following long-term antiretroviral therapy: 4 fatal cases. Int J STD AIDS. (Four patients with fatal lactic acidosis arising after long term therapy for HIV, all on stavudine and 3 on didanosine as well for 6-18 months, presenting with nausea, abdominal pain and weight loss with pH 7.04-7.17; autopsies in 2 showed severe hepatomegaly, micro- and macro-steatosis, and cholestasis).
Gérard Y, Maulin L, Yazdanpanah Y, De La Tribonniè X, Amiel C, Maurage CA, Robin S, et al. (2000). Symptomatic hyperlactataemia: an emerging complication of antiretroviral therapy. AIDS. (Identified 14 patients with symptoms of elevated lactate [levels 0.9 to 9.4 mmol/L] with fatigue, abdominal pain, weight loss, neuropathy and dyspnea on exertion, all on stavudine [9 also on didanosine] for 2-29 months).
Brivet FG, Nion I, Mérbane B, Slama A, Brivet M, Rustin P, Munnich A. (2000). Fatal lactic acidosis and liver steatosis associated with didanosine and stavudine treatment: a respiratory chain dysfunction?. J Hepatol. (Patient with HIV on didanosine and stavudine for 9 months developed nausea and anorexia, [bilirubin 1.2 mg/dL, ALT 206 U/L] and progressive lactic acidosis leading to death 5 days later; autopsy showed pancreatitis and hepatomegaly with severe macrovesicular steatosis).
Claessens Y-E, Cariou A, Chiche J-D, Dauriat G, Dhainaut J-F. (2000). L-carnitine as a treatment of life-threatening lactic acidosis induced by nucleoside analogues. AIDS. (34 year old man developed abdominal pain and nausea 11 months after starting stavudine, didanosine and saquinavir with severe lactic acidosis, cholestasis and fatty liver; given intravenous L-carnitine and slowly recovered).
Lonergan JT, Behling C, Pfander H, Hassanein TI, Mathews WC. (2000). Hyperlactatemia and hepatic abnormalities in 10 human immunodeficiency virus-infected patients receiving nucleoside analogue combination regimens. Clin Infect Dis. (Over a 6 month period, 10 HIV-positive patients presented with hyperlactatemia [2.9-6.2 mmol/L]; all were taking stavudine, 5 also on didanosine and 7 lamivudine for 4-20 months; 8 with symptoms of abdominal pain, nausea or distension; all with ALT elevations [2-10.7 times ULN], 3 with HBV or HCV; imaging showed fatty liver in 5; all resolved with stopping, lactate levels falling to normal after 16 to 111 days).
Ware AJ, Berggren RA, Taylor WE. (2000). Didanosine-induced hepatitis. Am J Gastroenterol. (36 year old man with HIV infection developed nausea 3 months after didanosine was added to antiretroviral regimen of stavudine nelfinavir, and nevirapine [bilirubin 1.5 mg/dL ALT 217 U/L, Alk P normal], resolving on stopping and recurring 3 months after didanosine and stavudine [without nelfinavir] were restarted [peak bilirubin 14.5 mg/dL, ALT 241 U/L Alk P 121 U/L], biopsy showing acute and chronic inflammatory changes, hepatocyte necrosis and fibrosis without fat: Case 3).
Sulkowski MS, Thomas DL, Chaisson RE, Moore RD. (2000). Hepatotoxicity associated with antiretroviral therapy in adults infected with human immunodeficiency virus and the role of hepatitis C or B virus infection. JAMA. (Among 298 patients with HIV infection, ALT elevations above 5 times ULN occurred in 10.4% per year during antiretroviral treatment; factors associated with ALT elevations included ritonavir [27.3%] and coinfection with either HCV or HBV; ALT with bilirubin elevations occurred in 3 patients; 2 on indinavir and all 3 with coinfection).
Carr A, Miller J, Law M, Cooper DA. (2000). A syndrome of lipoatrophy, lactic acidaemia and liver dysfunction associated with HIV nucleoside analogue therapy: contribution to protease inhibitor-related syndrome. AIDS. (Description of 14 patients with lipodystrophy who never received protease inhibitors, but most had received stavudine [86%], didanosine [71%] for >6 months and most had hyperlactatemia, ALT elevations and weight loss, nausea and fatigue, most resolved slowly upon withdrawal).
John M, Moore CB, James IR, Nolan D, Upton RP, McKinnon EJ, Mallal SA. (2001). Chronic hyperlactatemia in HIV-infected patients taking antiretroviral therapy. AIDS. (349 patients with HIV infection were screened for lactate levels on multiple occasions; 2 had symptomatic lactic acidosis and were both on stavudine: estimated incidence at 3.9 per 1000 person years).
Coghlan ME, Sommadossi JP, Jhala NC, Many WJ, Saag MS, Johnson VA. (2001). Symptomatic lactic acidosis in hospitalized antiretroviral-treated patients with human immunodeficiency virus infection: a report of 12 cases. Clin Infect Dis. (Experience with 12 cases of lactic acidosis in patients with HIV infection seen over 6 years: cases typically presented with anorexia, nausea and weight loss for several weeks, AST levels were variably elevated; 11 patients were on stavudine, 9 didanosine, 1 zidovudine alone; 6 had pancreatitis; 6 had liver biopsies, all of which showed macro- and micro-steatosis; five died).
Boubaker K, Flepp M, Sudre P, Furrer H, Haensel A, Hirschel B, Boggian K, et al. (2001). Hyperlactatemia and antiretroviral therapy: the Swiss HIV Cohort Study. Clin Infect Dis. (Cross sectional analysis of lactate testing on 880 Swiss patients with HIV receiving antiretroviral therapy; elevated levels were associated with stavudine and didanosine use and with lipodystrophy [and high glucose and triglycerides], but not age, sex, CD4 counts or HIV RNA levels).
Lederman JC, Nawaz H. (2001). Toxic interaction of didanosine and acetaminophen leading to severe hepatitis and pancreatitis: a case report and review of the literature. Am J Gastroenterol. (Patient on didanosine for 1 month took 4 g of acetaminophen over 3 days period and developed jaundice and ascites [bilirubin 15.1 mg/dL, ALT 280 IU/L, Alk P 280 IU/L], resolving completely after stopping didanosine).
Carr A, Morey A, Mallon P, Williams D, Thorburn DR. (2001). Fatal portal hypertension, liver failure, and mitochondrial dysfunction after HIV-1 nucleoside analogue-induced hepatitis and lactic acidaemia. Lancet. (65 year old developed hyperlactatemia and ascites 14 months after starting didanosine and stavudine [lactate 7 mmol/L, no acidosis, ALT 181 U/L], recovered slowly after stopping, but presented 1 year later with signs of portal hypertension, ascites, encephalopathy and varices; biopsy did not show cirrhosis; possibly nodular regenerative hyperplasia).
Church JA, Mitchell WG, Gonzalez-Gomez I, Christensen J, Vu TH, Dimauro S, Boles RG. (2001). Mitochondrial DNA depletion, near-fatal metabolic acidosis, and liver failure in an HIV-infected child treated with combination antiretroviral therapy. J Pediatr. (2 year old treated for 18 months with didanosine, zidovudine and nelfinavir developed lactic acidosis and hepatic failure [bilirubin 30.6 mg/dL, AST 224 U/L], resolving slowly after stopping drugs).
Clark SJ, Creighton S, Portmann B, Taylor C, Wendon JA, Cramp ME. (2002). Acute liver failure associated with antiretroviral treatment for HIV: a report of six cases. J Hepatol. (6 patients with HIV infection who developed acute liver failure on stavudine [n=5], lamivudine [n=3], didanosine [n=2], saquinavir [n=2], efavirenz [n=2], nevirapine [n=2], and nelfinavir, delavirdine or zidovudine [n=1] for 1-3 months [peak bilirubin 2.7-32 mg/dL, AST 240-8650 U/L, Alk P 122-191 U/L]; 2 with signs of hypersensitivity; 2 with hepatitis B; 5 died, autopsies showing massive necrosis; one with massive steatosis; likely multiple causes).
Lemberg DA, Palasanthiran P, Goode M, Ziegler JB. (2002). Tolerabilities of antiretrovirals in paediatric HIV infection. Drug Saf. (Review of adverse events to antiretroviral agents in children; rates of hepatotoxicity appear to be similar in children as adults, mitochondrial toxicity is rare, but deaths due to pancreatitis and liver failure have been reported in children on didanosine).
Falcó V, Rodríguez D, Ribera E, Martínez E, Miró JM, Domingo P, Diazaraque R, et al. (2002). Severe nucleoside-associated lactic acidosis in human immunodeficiency virus-infected patients: report of 12 cases and review of the literature. Clin Infect Dis. (Between 1997-2000, 12 cases of lactic acidosis were identified in HIV-infected patients at 4 hospitals in Spain; ~1:1000 patient-years of treatment; all receiving nucleoside analogue for 1-36 months, 1 attributed to zidovudine, 11 to stavudine [1 also on didanosine] with ALT 30-524 U/L; 33% fatality rate).
Moyle GJ, Datta D, Mandalia S, Morlese J, Asboe D, Gazzard BG. (2002). Hyperlactataemia and lactic acidosis during antiretroviral therapy: relevance, reproducibility and possible risk factors. AIDS. (Retrospective analysis of results of testing for lactate levels in 1239 patients with HIV infection, 108 [9%] had elevated levels >2.5 mmol/L and 9 [1%] >5 mmol/L, of whom 4 had lactic acidosis and 2 died; in multivariate analysis, elevations were associated with didanosine use and female sex).
Spengler U, Lichterfeld M, Rockstroh JK. (2002). Antiretroviral drug toxicity - a challenge for the hepatologist?. J Hepatol. (Review of the diagnosis of drug induced liver disease in patients with HIV on antiretroviral agents, with discussion of mechanisms including mitochondrial toxicity and hypersensitivity reactions).
Hillaire S, Bonte E, Denninger MH, Casadevall N, Cadranel JF, Lebrec D, Valla D, et al. (2002). Idiopathic non-cirrhotic intrahepatic portal hypertension in the West: a re-evaluation in 28 patients. Gut. (Among 28 cases of NCPH diagnosed between 1994 and 1998, none were diagnosed with HIV infection and no discussion of drug relatedness or didanosine; 12 had a prothrombotic disorder).
Thio CL, Seaberg EC, Skolasky R, Phair J, Visscher B, Muñoz A, Thomas DL, Multicenter AIDS Cohort Study. (2002). HIV-1, hepatitis B virus, and risk of liver-related mortality in the Multicenter Cohort Study (MACS). Lancet. (Cohort study of 5293 men who have sex with men followed for an average of 10.5 years found liver related mortality highest in HIV/HBV coinfected [1.4% yearly] than in HIV monoinfected [0.2%] or those with HBsAg alone [0.08%]).
Koch RO, Graziadel IW, Zangerle R, Romani N, Maier H, Vogel W. (2003). Acute hepatic failure and lactic acidosis associated with antiretroviral treatment for HIV. Wien Klin Wochenschr. (36 year old woman with HIV developed nausea and abdominal pain 18 months after starting didanosine and stavudine [bilirubin 1.2.12.0 mg/dL, ALT 40.177 U/L], with pancreatitis, lactic acidosis, hepatic encephalopathy and ascites, recovered slowly upon stopping drugs; liver biopsy showed microvesicular fat and cholestasis, with little inflammation).
Cornejo-Juárez P, Sierra-Madero J, Volkow-Fernández P. (2003). Metabolic acidosis and hepatic steatosis in two HIV-infected patients of stavudine (d4T) treatment. Arch Med Res. (1 woman and 1 man developed fatigue and jaundice 5 and 1 months after switching to an antiretroviral regimen that included stavudine [bilirubin 14.3 and 27.0 mg/dL, ALT 45 and 62U/L, Alk P 835 and 296 U/L], with lactic acidosis, hepatic steatosis and fatal outcome).
Murphy MD, O., Hearn M, Chou S. (2003). Fatal lactic acidosis and acute renal failure after addition of tenofovir to an antiretroviral regimen containing didanosine. Clin Infect Dis. (49 year old man with HIV infection and renal insufficiency on long term didanosine developed fatal lactic acidosis 6 weeks after starting tenofovir [lactate 5.5 rising to 16.7 mmol/L]; no mention of liver injury).
Bonnet F, Bonarek M, Morlat P, Mercie P, Dupon M, Gemain MC, Malvy D, et al. (2003). Risk factors for lactic acidosis in HIV-1-infected patients treated with nucleoside reverse-transcriptase inhibitors: a case-control study. Clin Infect Dis. (Case control study of 9 patients [5 women] with HIV infection and lactic acidosis, 6 with hepatomegaly and 5 with jaundice, 8 on stavudine, 7 on didanosine, 6 on zidovudine; 6 died; risk factors were renal insufficiency and low CD4 counts but numbers of cases were few).
Arenas-Pinto A, Grant AD, Edwards S, Weller IVD. (2003). Lactic acidosis in HIV-1 infected patients: a systematic review of published cases. Sex Transm Infect. (Review of 217 published cases of lactic acidosis; 53% female, all taking at least one nucleoside for 1-36 months, 61% on stavudine, 33% didanosine, 31% zidovudine, 30% lamivudine; 92% had hepatic steatosis on biopsy or autopsy; 48% died).
Kontorinis N, Dieterich D. (2003). Hepatotoxicity of antiretroviral therapy. AIDS Rev. (Review of hepatotoxicity of antiretroviral drugs; definition of hepatotoxicity in antiretroviral studies; grade 1=1.25-2.5 times, grade 2=2.6-5 times, grade 3=5.1-10 times and grade 4=>10 times ULN or baseline ALT values; abacavir and lamivudine are least likely to cause hepatotoxicity).
Ogedegbe AE, Thomas DL, Diehl AM. (2003). Hyperlactataemia syndromes associated with HIV therapy. Lancet Infect Dis. (Review of mechanisms of hyperlactatemia with antiretroviral therapy, occurs mostly with use of nucleoside analogues, stavudine, didanosine and zidovudine, attributed to mitochondrial depletion, but other mechanisms may be involved).
Ofotokun I, Pomeroy C. (2003). Sex differences in adverse reactions to antiretroviral drugs. Top HIV Med. (Review of sex differences in adverse events; higher frequency of mitochondrial toxicity and hypersensitivity in women than men).
Ogedegbe AO, Sulkowski MS. (2003). Antiretroviral-associated liver injury. Clin Liver Dis. (Review of hepatotoxicity of antiretrovirals; ALT elevations above 5 times ULN reported in 7% with zidovudine, 16% didanosine, 9-13% stavudine, <1% lamivudine, tenofovir and abacavir, 3-10% protease inhibitors, 10% nevirapine and 8% efavirenz; recommend monitoring at 4 weeks and then every 12 weeks, stopping if ALT levels are >10 times ULN or if symptoms of liver injury are present, monitoring more closely if ALT levels are elevated).
Pecora Fulco P, Kirian MA. (2003). Effect of tenofovir on didanosine absorption in patients with HIV. Ann Pharmacother. (When given together, tenofovir increases plasma concentrations of didanosine).
Blanchard JN, Wohlfeiler M, Canas A, King K, Lonergan JT. (2003). Pancreatitis with didanosine and tenofovir disoproxil fumarate. Clin Infect Dis. (4 patients developed pancreatitis and lactic acidosis arising 2-6 months after adding tenofovir to HIV regimen including didanosine; 1 died, 3 who survived were able to restart tenofovir without didanosine; liver tests mentioned only in fatal case [bilirubin 5.3 mg/dL, ALT 89 U/L).
Rivas P, Polo J, de Gólas M, Fernáez-Guerrero ML. (2003). Drug Points: Fatal lactic acidosis associated with tenofovir. BMJ. (45 year old woman with HIV-HCV co-infection on long term didanosine and stavudine developed jaundice 8 weeks after switching from nevirapine to tenofovir [bilirubin 12.6 mg/dL, ALT 157 U/L], CT showed fatty liver; despite stopping antivirals, lactic acidosis worsened and she died 36 hours later: Case 2).
Callens S, De Schacht C, Huyst V, Colebunders R. (2003). Pancreatitis in an HIV-infected person on a tenofovir, didanosine and stavudine containing highly active antiretroviral treatment. J Infect. (33 year old woman developed pancreatitis 5 months after starting didanosine and 1 month after addition of tenofovir to HIV regimen [bilirubin not given, ALT 386 U/L, Alk P 208 U/L, amylase 11395 U/L], resolving rapidly when antivirals were stopped).
Walker UA, Bärle J, Laguno M, Murillas J, Mauss S, Schmutz G, Setzer B, et al. (2004). Depletion of mitochondrial DNA in liver under antiretroviral therapy with didanosine, stavudine, or zalcitabine. Hepatology. (Liver biopsies from 94 patients with chronic hepatitis C [80 with concurrent HIV] were assessed for mitochondrial DNA content, which was on average 50% lower in patients on zalcitabine, didanosine, or stavudine compared to other nucleoside analogues; usually required 6 months or more of therapy).
Guo Y, Fung HB. (2004). Fatal lactic acidosis associated with coadministration of didanosine and tenofovir disoproxil fumarate. Pharmacotherapy. (63 year old man with HIV and HCV developed fatal lactic acidosis 1.5 years after starting didanosine-tenofovir-lopinavir-ritonavir regimen, with pancreatitis, multiorgan failure and death; liver injury not mentioned).
Fleischer R, Boxwell D, Sherman KE. (2004). Nucleoside analogues and mitochondrial toxicity. Clin Infect Dis. (Among 31 HIV-HCV coinfected patients reported to the FDA with severe mitochondrial toxicity, 90% had received didanosine, 71% stavudine and combination with ribavirin seemed to increase the risk).
Sulkowski MS, Mehta SH, Torbenson M, Afdhal NH, Mirel L, Moore RD, Thomas DL. (2005). Hepatic steatosis and antiretroviral drug use among adults coinfected with HIV and hepatitis C virus. AIDS. (Among 112 patients with HIV-HCV coinfection undergoing liver biopsy, 40% had steatosis [which affected >5% of hepatocytes in 18%]; presence of fat correlated with white race, higher BMI, hyperglycemia, and stavudine use).
Abrescia N, D'Abbraccio M, Figoni M, Busto A, Maddaloni A, De Marco M. (2005). Hepatotoxicity of antiretroviral drugs. Curr Pharm Des. (Review of hepatotoxicity of antiretrovirals; major syndrome with nucleoside analogues is mitochondrial injury with lactic acidosis, hepatomegaly and steatosis).
Masiá M, Gutiérrez F, Padilla S, Ramos JM, Pascual J. (2005). Severe toxicity associated with the combination of tenofovir and didanosine: case report and review. Int J STD AIDS. (45 year old man with HIV-HCV coinfection developed lactic acidosis and "mild cholestasis" 3 months after adding tenofovir to didanosine, resolving slowly after stopping therapy).
Weber R, Sabin CA, Friis-Møller N, Reiss P, El-Sadr WM, Kirk O, Dabis F, et al. (2006). Liver-related deaths in persons infected with the human immunodeficiency virus: the D:A:D study. Arch Intern Med. (Cohort study of 23,441 HIV infected persons followed for a median of 3.5 years identified 1246 deaths [1.6% per year] caused by AIDS [31%], liver disease [14.5%], cardiovascular [11%], cancer [9.4%]; 70% of liver related were due to HCV or HBV and associated with low CD4 counts).
Maida I, Núñez M, Ríos MJ, Martín-Carbonero L, Sotgiu G, Toro C, Rivas P, et al. (2006). Severe liver disease associated with prolonged exposure to antiretroviral drugs. J Acquir Immune Defic Syndr. (Among 3200 HIV-infected persons followed in 2 large Spanish cohorts, 17 [0.5%] had severe chronic liver disease of unknown cause [bilirubin normal in all except one, ALT 25-131 U/L, Alk P 114-430 U/L], 4 with cirrhosis, all had long term exposure to didanosine [mean = 4 years]).
Podevin P, Spiridon G, Terris B, Chauvelot-Moachon L, Guillevin L, Chaussade S, Sogni P, Salmon-Ceron D. (2006). Nodular regenerative hyperplasia of the liver after IL-2 therapy in an HIV-infected patient. AIDS. (65 year old man with HIV infection on antiretroviral therapy including didanosine for 7 years presented with ascites and esophageal varices 2 months after starting IL2 therapy [bilirubin and ALT normal, Alk P ~525 U/L], liver biopsy showing nodular regenerative hyperplasia).
Mallet V, Blanchard P, Verkarre V, Vallet-Pichard A, Fontaine H, Lascoux-Combe C, Pol S. (2007). Nodular regenerative hyperplasia is a new cause of chronic liver disease in HIV-infected patients. AIDS. (Description of 8 patients with HIV infection presenting between 2003 and 2006 with cryptogenic liver disease, ages 33-59 years, 4 men and 4 women, with evidence of portal hypertension, 3 with ascites, all with esophageal varices and thrombocytopenia [71-149,000/uL], bilirubin 0.4-2.0 mg/dL, minimal ALT, AST and Alk P elevations, often with low CD4 counts, all receiving didanosine, liver biopsies showing nodular regenerative hyperplasia).
Arey B, Markov M, Ravi J, Prevette E, Batts K, Nadir A. (2007). Nodular regenerative hyperplasia of liver as a consequence of ART. AIDS. (Letter in response to Mallet [2007] describing a 27 year old man who presented with splenomegaly and varices [bilirubin 0.6 mg/dL, ALT 109 U/L, Alk P 165 U/L] 4 weeks after switching from didanosine [given for 4 years] to nevirapine).
Sandrine PF, Sylvie A, André E, Abdoulaye D, Bernard L, André C. (2007). Nodular regenerative hyperplasia: a new serious antiretroviral drugs side effect?. AIDS. (Letter in response to Mallet [2007] describing a patient with noncirrhotic portal hypertension from Martinque; 49 year old woman treated with didanosine for 9 years had chronic enzyme elevations and developed thrombocytopenia, ascites and varices, showing nodular regeneration).
Garvey LJ, Thomson EC, Lloyd J, Cooke GS, Goldin RD, Main J. (2007). Response to Mallet et al., 'Nodular regenerative hyperplasia is a new cause of chronic liver disease in HIV-infected patients'. AIDS. (Letter in response to Mallet [2007] describing 6 HIV infected patients with unexplained portal hypertension, ages 26-48 years, 5 had received didanosine for >2 years, 1 died of variceal hemorrhage).
Schiano TD, Kotler DP, Ferran E, Fiel MI. (2007). Hepatoportal sclerosis as a cause of noncirrhotic portal hypertension in patients with HIV. Am J Gastroenterol. (Description of 4 men with HIV infection, ages 35-60 years, who presented with esophageal varices [bilirubin 0.5-1.6 mg/dL, ALT 37-95 U/L, Alk P 103-316 U/L, INR 1.0-1.3, platelets 85-135,000/μL], biopsy showing hepatoportal sclerosis with cirrhosis; no mention of didanosine exposure).
Lapadula G, Izzo I, Costarelli S, Cologni G, Bercich L, Casari S, Gambarotti M, et al. (2007). Dideoxynucleoside HIV reverse transcriptase inhibitors and drug-related hepatotoxicity: a case report. J Med Case Rep. (43 year old woman with HIV infection on stavudine for 3 years and tenofovir for 6 months developed rising ALT levels [222 to 392 U/L], which persisted despite stopping indinavir and resolved slowly on stopping stavudine; liver biopsy showed inflammation, fat and Mallory bodies).
Jain MK. (2007). Drug-induced liver injury associated with HIV medications. Clin Liver Dis. (Review of hepatotoxicity of antiretroviral medications; ALT elevations occur in 2-18% of patients, but often resolve spontaneously even without dose modification; classes of injury include hypersensitivity [nevirapine, efavirenz, abacavir], mitochondrial injury [stavudine, didanosine, zidovudine], flares of hepatitis B [lamivudine, emtricitabine, tenofovir], flares of hepatitis C [any potent regimen], idiosyncratic injury [ritonavir, nevirapine, efavirenz], and cholestatic hepatitis [many agents]).
Mallet V, Blanchard P, Verkarre V, Vallet-Pichard A, Fontaine H, Lascoux-Combe C, Pol S. (2007). Nodular regenerative hyperplasia is a new cause of chronic liver disease in HIV-infected patients. AIDS. (Among 8 patients with HIV infection referred for evaluation of liver disease of unknown cause, all had nodular regenerative hyperplasia and had received didanosine [and many received stavudine or zidovudine] for 1-2 years [bilirubin 0.2-2.0 mg/dL, ALT 0.4-2.0 times ULN, Alk P 0.9-19.1 times ULN, platelets 71-149,000/μL], all had varices and 5 had ascites).
Wester CW, Okezie OA, Thomas AM, Bussmann H, Moyo S, Muzenda T, Makhema J, et al. (2007). Higher-than-expected rates of lactic acidosis among highly active antiretroviral therapy-treated women in Botswana: preliminary results from a large randomized clinical trial. J Acquir Immune Defic Syndr. (Among 650 patients starting antiretroviral therapy, 2% developed hyperlactatemia [>4.4 mmol/L] and 1% lactic acidosis [all female, trend towards older age and higher body mass index], all on stavudine, didanosine, and/or zidovudine; 6 died, 4 of pancreatitis).
Bolhaar MG, Karstaedt AS. (2007). A high incidence of lactic acidosis and symptomatic hyperlactatemia in women receiving highly active antiretroviral therapy in Soweto, South Africa. Clin Infect Dis. (Among 1735 adults with HIV infection started on antiretroviral therapy, 3% developed hyperlactatemia; 23 [1%] with lactic acidosis [22 were women and 22 were on stavudine, 1 on didanosine and zidovudine], 30% mortality; 44 had symptomatic hyperlactatemia [37 women, all 44 on stavudine, 3 also with didanosine], able to switch to zidovudine without recurrence, 2 of 3 relapsed on restarting stavudine).
Lactic Acidosis International Study Group. (2007). Risk factors for lactic acidosis and severe hyperlactataemia in HIV-1-infected adults exposed to antiretroviral therapy. AIDS. (Retrospective case control study of 110 cases of hyperlactataemia and 220 controls, identified risk factors of older age, female gender, lower CD4 counts, and use of stavudine, didanosine or both).
Thoden J, Lebrecht D, Venhoff N, Neumann J, Muller K, Walker UA. (2008). Highly active antiretroviral HIV therapy-associated fatal lactic acidosis: quantitative and qualitative mitochondrial DNA lesions with mitochondrial dysfunction in multiple organs. AIDS. (62 year old man developed high lactate levels [3.7 mmol/L] without acidosis or symptoms 16 months after starting didanosine-stavudine-efavirenz, and 2 months later developed fatal lactic acidosis and multiorgan failure; mitochondrial copy numbers assessed in multiple organs being reduced to 7% of normal levels in liver, 20% in kidney, 28% in muscle and 72% in heart).
Maida I, Garcia-Gasco P, Sotgiu G, Rios MJ, Vispo ME, Martin-Carbonero L, Barreiro P, et al. (2008). Antiretroviral-associated portal hypertension: a new clinical condition? Prevalence, predictors and outcome. Antivir Ther. (Among 3200 HIV-infected persons in 2 large Spanish cohorts, 17 [0.5%] had severe chronic liver disease of unknown cause [bilirubin normal in 16, ALT 25-131 U/L, Alk P 114-430 U/L], 4 with cirrhosis, all had long term exposure to didanosine [mean=4 years]).
Saifee S, Joelson D, Braude J, Shrestha R, Johnson M, Sellers M, Galambos MR, Rubin RA. (2008). Noncirrhotic portal hypertension in patients with human immunodeficiency virus-1 infection. Clin Gastroenterol Hepatol. (Description of 11 patients with HIV infection and noncirrhotic portal hypertension [bilirubin 0.4-3.2 mg/dL, ALT 13-99 U/L, Alk P 112-419 U/L, platelets 77-581,000/μL], often with protein S or C deficiency; all had received didanosine and had nodular regenerative hyperplasia; 5 had ascites and 1 died of esophageal variceal bleeding).
Tateo M, Sebagh M, Bralet MP, Teicher E, Azoulay D, Mallet V, Pol S, et al. (2008). A new indication for liver transplantation: nodular regenerative hyperplasia in human immunodeficiency virus-infected patients. Liver Transpl. (Description of 3 patients with HIV infection and nodular regenerative hyperplasia who underwent liver transplantation, 2 women and 1 man, ages 38 to 43 years, having received didanosine for 3-8 years, 2 with portal vein thrombosis, all with varices [bilirubin 1.3-3.6 mg/dL, INR 1.2-1.6, creatinine 0.6-1.1 mg/dL], all were alive without liver abnormalities 3-7 months after deceased donor liver transplantation).
Vispo E, Maida I, Barreiro P, Moreno V, Soriano V. (2008). Upper gastrointestinal bleeding may unmask didanosine-associated portal hepatopathy in HIV/HCV co-infected patients. HIV Clin Trials. (3 patients with HIV-HCV coinfection presented with signs of portal hypertension, but had little evidence of advanced fibrosis and only mild liver test abnormalities; all 3 had received didanosine [for 30-64 months] and HIV RNA levels were undetectable; liver biopsies not done).
Hammer SM, Eron JJ, Reiss P, Schooley RT, Thompson MA, Walmsley S, Cahn P, et al., International AIDS Society-USA. (2008). Antiretroviral treatment of adult HIV infection: 2008 recommendations of the International AIDS Society-USA panel. JAMA. (Updated recommendations on use of antiviral therapy in adults with HIV infection including use of recently approved agents raltegravir, maraviroc and etravirine).
Inductivo-Yu I, Bonacini M. (2008). Highly active antiretroviral therapy-induced liver injury. Current Drug Safety. (Review of drug induced liver injury due to antiretroviral agents).
Soriano V, Puoti M, Garcia-Gascó Rockstroh JK, Benhamou Y, Barreiro P, McGovern B. (2008). Antiretroviral drugs and liver injury. AIDS. (Review of hepatotoxicity of antiretroviral drugs with recommendations on management, stopping therapy if symptoms arise, with overt jaundice [direct bilirubin], evidence of mitochondrial toxicity, ALT >10 times ULN, ALT at lower levels if newly marketed agent; important to rule out other causes: problematic agents include didanosine, stavudine and zidovudine; nevirapine and efavirenz, full dose ritonavir and tipranavir).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, 7 were attributed to antiretroviral agents, 2 nevirapine, 1 efavirenz and 4 miscellaneous combinations, but none with didanosine).
Panos G, Farouk L, Stebbing J, Holmes P, Valero S, Randell P, Bower M, et al. (2009). Cryptogenic pseudocirrhosis: a new clinical syndrome of noncirrhotic portal hypertension (unassociated with advanced fibrosis) that can be detected by transient elastography in patients with HIV. J Acquir Immune Defic Syndr. (Among 5 patients with noncirrhotic portal hypertension [NCPH] identified by elastography rather than symptoms or signs, all had received didanosine and biopsies showed portal fibrosis only).
Chang PE, Miquel R, Blanco JL, Laguno M, Bruguera M, Abraldes JG, Bosch J, Garcia-Pagan JC. (2009). Idiopathic portal hypertension in patients with HIV infection treated with highly active antiretroviral therapy. Am J Gastroenterol. (Among 8 patients with HIV infection and NCPH, all had received didanosine, hepatic venous pressure gradients were 3.5 to 14.5 mm Hg, underestimating degree of portal pressure, and elastography measurements were unreliable; 6 patients developed portal vein thrombosis).
Mendizabal M, Craviotto S, Chen T, Silva MO, Reddy KR. (2009). Noncirrhotic portal hypertension: another cause of liver disease in HIV patients. Ann Hepatol. (Description of 6 patients with HIV infection and NCPH, ages 37 to 47 years presenting with varices, 2 with ascites and 2 with portal vein thrombosis, biopsies showing nodular regenerative hyperplasia in 2, hepatoportal sclerosis in 1 and both in 3 [bilirubin 1.1-1.4 mg/dL, ALT 13-73 U/L, platelets 65-273,000/μL], 4 having been exposed to didanosine).
Ingiliz P, Valantin MA, Duvivier C, Medja F, Dominguez S, Charlotte F, Tubiana R, et al. (2009). Liver damage underlying unexplained transaminase elevation in human immunodeficiency virus-1 mono-infected patients on antiretroviral therapy. Hepatology. (Among 30 patients with HIV infection and unexplained ALT or AST elevations, liver biopsies showed NASH in 16, fibrosis in 19 and cirrhosis in 3; abnormalities did not correlate with any one antiretroviral agent).
Kovari H, Ledergerber B, Peter U, Flepp M, Jost J, Schmid P, Calmy A, et al., Swiss HIV Cohort Study. (2009). Association of noncirrhotic portal hypertension in HIV-infected persons and antiretroviral therapy with didanosine: a nested case-control study. Clin Infect Dis. (15 patients with noncirrhotic portal hypertension [NCPH] were identified between 2000-2007 in a large Swiss cohort of HIV-infected persons and compared to 75 matched controls; those with NCPH were older [52 vs 43 years], with lower CD4 counts, higher ALT and Alk P, lower platelet counts; all had received didanosine and 4 died of liver disease).
Dinh MH, Stosor V, Rao SM, Miller FH, Green RM. (2009). Cryptogenic liver disease in HIV-seropositive men. HIV Med. (Among 9 patients with HIV infection referred for evaluation of liver disease of unknown cause, 3 had nodular regenerative hyperplasia and several others had portal hypertension without cirrhosis; no mention of antiretroviral regimens).
Mendizabal M, Craviotto S, Chen T, Silva MO, Reddy KR. (2009). Noncirrhotic portal hypertension: another cause of liver disease in HIV patients. Ann Hepatol. (Description of 6 patients with HIV infection and noncirrhotic portal hypertension; ages 37 to 47 years, on long term [8-18 years] antiretroviral therapy including didanosine in 4; all had esophageal varices, 5 with bleeding and 2 with ascites; liver biopsies showed NRH in 2, HPS in 1 and both patterns in 3).
Lafeuillade A, Hittinger G, Cheret A, Poggi C. (2009). Didanosine withdrawal is associated with improved liver function tests. HIV Clin Trials. (Letter describing 38 patients with HIV infection on didanosine for 3-8 years who were switched to a protease inhibitor regimen and followed; all remained HIV RNA negative and had decreases in means of ALT [47 to 29 U/L] and AST [54 to 30 U/L]).
Ferrajolo C, Capuano A, Verhamme KM, Schuemie M, Rossi F, Stricker BH, Sturkenboom MC. (2010). Drug-induced hepatic injury in children: a case/non-case study of suspected adverse drug reactions in VigiBase. Br J Clin Pharmacol. (Worldwide pharmacovigilance database contained 9036 hepatic adverse drug reactions in children, 3 antiretroviral agents were among the top 41 causes, including zidovudine [8th, 106 cases], lamivudine [26th, 45 cases] and nevirapine [36th, 37 cases]).
Merchante N, Pérez-Camacho I, Mira JA, Rivero A, Macías J, Camacho A, Gómez-Mateos J, et al., Grupo Andaluz para el Estudio de las Hepatitis Víricas de la Sociedad Andaluza de Enfermedades Infecciosas. (2010). Prevalence and risk factors for abnormal liver stiffness in HIV-infected patients without viral hepatitis coinfection: role of didanosine. Antivir Ther. (Among 258 patients with HIV infection without hepatitis B or C who underwent ultrasound elastography, elevated values [>7.2 kPa] were found in 29 patients; these abnormalities were associated independently with time on didanosine).
Palacios R, Rivero A, Santos I, Ríos MJ, Castaño M, del Arco A, Santos González J. (2010). VITOX Group. Rapid improvement in fasting lipids and hepatic toxicity after switching from didanosine/lamivudine to tenofovir/emtricitabine in patients with toxicity attributable to didanosine. HIV Clin Trials. (Among 147 patients with HIV infection switched from didanosine to tenofovir, fasting lipids and liver test abnormalities were said to be improved in all, although mean ALT and AST values did not change).
Vispo E, Moreno A, Maida I, Barreiro P, Cuevas A, Albertos S, Soriano V. (2010). Noncirrhotic portal hypertension in HIV-infected patients: unique clinical and pathological findings. AIDS. (Clinical description of 12 patients with HIV infection on long term antiretroviral therapy with didanosine presenting with portal hypertension without cirrhosis, 11 biopsies showing nodular regenerative hyperplasia [NRH =3] or hepatoportal sclerosis [HPS = 8]; patient ages 39-67 years, 2 women and 10 men, ALT 23-196 U/L, 5 with variceal bleeding and 2 with ascites).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury and 4 to antiretroviral agents, including 2 to the combination of didanosine and stavudine).
Hartleb M, Gutkowski K, Milkiewicz P. (2011). Nodular regenerative hyperplasia: evolving concepts on underdiagnosed cause of portal hypertension. World J Gastroenterol. (Review of etiology, course and management of nodular regenerative hyperplasia; mentions its association with azathioprine, mercaptopurine, thioguanine, oxaliplatin and antiretroviral agents).
Scourfield A, Jackson A, Waters L, Gazzard B, Nelson M. (2011). The value of screening HIV-infected individuals for didanosine-related liver disease?. Antivir Ther. (Among 2070 patients with HIV infection, 26 presented with idiopathic portal hypertension, all having received didanosine [mean of 66 months], with mild ALT and Alk P elevations only).
Dlamini J, Ledwaba L, Mokwena N, Mokhathi T, Orsega S, Tsoku M, Kowo H, et al. (2011). Lactic acidosis and symptomatic hyperlactataemia in a randomized trial of first-line therapy in HIV-infected adults in South Africa. Antivir Ther. (Among 1771 patients with HIV infection treated with one of 4 antiviral regimens with didanosine or stavudine, 13 developed lactic acidosis [3.5/1000 patient-years]; lactic acidosis cases were more likely female, with higher BMI and exposure to stavudine).
Feeney ER, Chazallon C, O'Brien N, Meiffrédy V, Goodall RL, Aboulker JP, Cooper DA, Yeni P, Mallon PW, INITIO Trial International Co-ordinating Committee. (2011). Hyperlactataemia in HIV-infected subjects initiating antiretroviral therapy in a large randomized study (a substudy of the INITIO trial). HIV Med. (Among 911 patients with HIV infection started on antiretroviral therapy with didanosine and stavudine, 24 developed elevated lactate levels; abnormalities were more frequent in women than men and those with higher BMI; not predicted by or accompanied by peripheral lymphocyte mitochondrial DNA levels).
Cachay ER, Peterson MR, Goicoechea M, Mathews WC. (2011). Didanosine exposure and noncirrhotic portal hypertension in a HIV clinic in North America: a follow-up study. Br J Med Med Res. (Among 8 men with HIV infection diagnosed with NCPH between 1990 and 2010 at a single University HIV clinic, all had been exposed to didanosine for a median of 37 [range 24-66] months, [bilirubin 0.5-2.0 mg/dL, ALT 24-86 U/L, Alk P 48-253 U/L, INR 1.0-1.2, platelet counts 47,000-136,000]; most were stable once didanosine was stopped with medical management of portal hypertension).
Alvarez Díaz H, Mariño Callejo A, García Rodríguez JF. (2011). Non-cirrhotic portal hypertension in human immunodeficiency virus-infected patients: a new challenge in antiretroviral therapy era. Open AIDS J. (Two patients with HIV infection developed portal hypertension on didanosine therapy; 58 year old man and 41 year old woman presented with esophageal varices after didanosine therapy for 1 and 5 years and remained stable after stopping).
Scourfield A, Waters L, Holmes P, Panos G, Randell P, Jackson A, Mandalia S, Gazzard B, Nelson M. (2011). Non-cirrhotic portal hypertension in HIV-infected individuals. Int J STD AIDS. (Among 17 patients with HIV infection and noncirrhotic portal hypertension, risk factors were prolonged didanosine exposure [59 vs 21 months]).
Hofmaenner D, Kovari H, Weber A, Weishaupt D, Speck RF. (2011). Nodular regenerative hyperplasia of the liver associated with didanosine persists for years even after its interruption. BMJ Case Rep. (47 year old man with HIV infection developed noncirrhotic portal hypertension 6-7 years after starting didanosine which was stopped; he remained stable, but still had varices and evidence of portal hypertension 10 years later).
Vispo E, Morello J, Rodriguez-Novoa S, Soriano V. (2011). Noncirrhotic portal hypertension in HIV infection. Curr Opin Infect Dis. (Review of the problem of noncirrhotic portal hypertension in patients with HIV infection, stressing the role of didanosine and possible role of bacterial translocation causing endothelial damage, thromboses and portal venopathy).
Schiano TD, Uriel A, Dieterich DT, Fiel MI. (2011). The development of hepatoportal sclerosis and portal hypertension due to didanosine use in HIV. Virchows Arch. (45 year old man with HIV infection developed nodular regenerative hyperplasia 5 years after starting a regimen of didanosine, stavudine and protease inhibitors that progressed despite switching to zidovudine, lamivudine, abacavir and tenofovir, with biopsy 5 years later showing hepatoportal sclerosis).
Cotte L, Bénet T, Billioud C, Miailhes P, Scoazec JY, Ferry T, Brochier C, et al. (2011). The role of nucleoside and nucleotide analogues in nodular regenerative hyperplasia in HIV-infected patients: a case control study. J Hepatol. (Case controlled study of 13 patients with HIV infection and nodular regenerative hyperplasia [NRH] and 78 HIV infected controls found that age, duration of didanosine and stavudine therapy were independently associated with NRH).
Blanco F, Barreiro P, Ryan P, Vispo E, Martín-Carbonero L, Tuma P, Labarga P, et al. (2011). Risk factors for advanced liver fibrosis in HIV-infected individuals: role of antiretroviral drugs and insulin resistance. J Viral Hepat. (Among 681 unselected patients with HIV infection undergoing ultrasound elastography, 215 had elevated values [>9.5 kPa], which were independently associated with HCV coinfection, ALT elevations, history of alcohol abuse, abnormal HOMA values and exposure to didanosine or stavudine).
Young J, Klein MB, Ledergerber B. (2011). Noncirrhotic portal hypertension and didanosine: a re-analysis. Clin Infect Dis. (Statistical reanalysis of the results from Kovari from "2020" concludes that the findings do "not appear to be an artifact").
Schouten JN, Van der Ende ME, Koëter T, Rossing HH, Komuta M, Verheij J, van der Valk M, et al. (2012). Risk factors and outcome of HIV-associated idiopathic noncirrhotic portal hypertension. Aliment Pharmacol Ther. (Comparison of 16 patients with HIV infection and NCPH vs 64 controls identified in the Netherlands, cases were younger [44 vs 52 years], had lower CD4 counts, higher ALT and Alk P, and more likely to have received didanosine [16] or stavudine [11] or both).
Suárez-Zarracina T, Valle-Garay E, Collazos J, Montes AH, Cárcaba V, Carton JA, Asensi V. (2012). Didanosine (ddI) associates with increased liver fibrosis in adult HIV-HCV coinfected patients. J Viral Hepat. (Among 111 patients with HIV/HCV coinfection, didanosine was associated with higher scores by transient elastography, a noninvasive means of assessing hepatic stiffness).
Giacomet V, Viganò A, Penagini F, Manfredini V, Maconi G, Camozzi M, Zuccotti GV. (2012). Splenomegaly and variceal bleeding in a ten-year-old HIV-infected girl with noncirrhotic portal hypertension. Pediatr Infect Dis J. (10 year old girl with HIV infection developed splenomegaly, ascites and varices having been on didanosine for 7 years [bilirubin 0.8 mg/dL, ALT 48 U/L, Alk P 231 U/L, platelets 154,000/μL], biopsy showing hepatoportal sclerosis).
Saison J, Cotte L, Chidiac C, Ferry T. (2012). Fatal cumulative toxicities of HAART in a stable, AIDS-free, HIV-infected patient. BMJ Case Rep. (57 year old man with HIV infection and severe lipodystrophy developed ascites 5 years after starting didanosine, biopsy showing nodular generative hyperplasia).
Jackson BD, Doyle JS, Hoy JF, Roberts SK, Colman J, Hellard ME, Sasadeusz JJ, et al. (2012). Non-cirrhotic portal hypertension in HIV mono-infected patients. J Gastroenterol Hepatol. (Among 1000 patients with HIV infection without HCV or HBV coinfection followed in Melbourne, Australia, 5 men, ages 40-611 years, had unexplained portal hypertension [bilirubin 0.4-0.7 mg/dL, ALT 25-82 U/L, Alk P 73-889 U/L, fibroscan 6.0-13 kPa], biopsy in 4 showing no cirrhosis).
Chang HM, Tsai HC, Lee SS, Wann SR, Chen YS. (2012). Noncirrhotic portal hypertension associated with didanosine: a case report and literature review. Jpn J Infect Dis. (80 year old Chinese man with HIV infected presented with ascites and esophageal varices 34 months after starting didanosine, lamivudine and nevirapine [bilirubin normal, ALT 36 U/L, Alk P 188 U/L, platelets 140,000/μL], with portal vein thrombosis and dying 3 months later of variceal bleed).
Dragovic G, Jevtovic D. (2012). The role of nucleoside reverse transcriptase inhibitors usage in the incidence of hyperlactatemia and lactic acidosis in HIV/AIDS patients. Biomed Pharmacother. (Among 396 patients with HIV infection started on antiretroviral therapy, hyperlactemia developed in 19 [none died] and lactic acidosis arose in 15 [4 died]; risk factors for lactic acidosis were exposure to didanosine [n=3], stavudine [n=4] or both [n=8]).
Arenas-Pinto A, Weller I, Ekong R, Grant A, Karstaedt A, Reiss P, Telisinghe L, et al. (2012). Common inherited mitochondrial DNA mutations and nucleoside reverse transcriptase inhibitor-induced severe hyperlactataemia in HIV-infected adults: an exploratory study. Antivir Ther. (Among 40 South African patients with HIV infection who developed hyperlactemia on stavudine based therapy, distribution of mitochondrial DNA haplotypes was the same as in controls).
Barlow-Mosha L, Eckard AR, McComsey GA, Musoke PM. (2013). Metabolic complications and treatment of perinatally HIV-infected children and adolescents. J Int AIDS Soc. (Review of metabolic complications [such as lipodystrophy and lactic acidosis] of long term antiretroviral therapy in children and adolescents).
Wagner TA, Lin CH, Tobin NH, Côté HC, Sloan DD, Jerome KR, Frenkel LM. (2013). Quantification of mitochondrial toxicity in HIV-infected individuals by quantitative PCR compared to flow cytometry. Cytometry B Clin Cytom. (Ratios of concentrations of mitochondrial vs nuclear DNA and proteins in peripheral blood mononuclear cells were similar in patients, with or without clinical evidence of mitochondrial injury due to antiretroviral therapy).
Hui YT, Lam WY, Lee MP, Lam TW, Li P. (2013). An unusual cause of oesophageal variceal bleeding in a Chinese human immunodeficiency virus-infected patient. Hong Kong Med J. (49 year old Chinese man with HIV infection developed variceal hemorrhage and was found to have hepatoportal sclerosis 5 years after stopping a 6 year course of didanosine).
Verheij J, Schouten JN, Komuta M, Nevens F, Hansen BE, Janssen HL, Roskams T. (2013). Histological features in western patients with idiopathic non-cirrhotic portal hypertension. Histopathology. (Histological analysis of 70 patients with NCPH, 13 with HIV infection who were more likely to have NRH [93% vs 46%] and who had a similar risk for underlying thrombophilic condition [31% vs 40%]).
Vispo E, Cevik M, Rockstroh JK, Barreiro P, Nelson M, Scourfield A, Boesecke C, et al., European Network of Clinical Trials (NEAT). (2013). Genetic determinants of idiopathic noncirrhotic portal hypertension in HIV-infected patients. Clin Infect Dis. (Case control study of 22 HIV infected patients with NCPH and 58 controls for single nucleotide polymorphisms in genes for enzymes involved in purine metabolism identified 2 single nucleotide polymorphisms in the 5-nucleotidase and 2 in the xanthine oxidase genes associated with presence of NCPH).
Sood A, Castrejón M, Saab S. (2014). Human immunodeficiency virus and nodular regenerative hyperplasia of liver: A systematic review. World J Hepatol. (A review of the literature on nodular regenerative hyperplasia in HIV infected patients).
Parikh ND, Martel-Laferriere V, Kushner T, Childs K, Vachon ML, Dronamraju D, Taylor C, et al. (2014). Clinical factors that predict noncirrhotic portal hypertension in HIV-infected patients: a proposed diagnostic algorithm. J Infect Dis. (Comparison of 35 HIV infected persons with NCPH to 68 controls identified multiple clinical differences; authors propose a diagnostic algorithm that includes exposure to didanosine, splenomegaly, low platelet count or serum enzyme elevations as suggestive of diagnosis and warranting further evaluation).
Yajima K, Uehira T, Otera H, Koizumi Y, Watanabe D, Kodama Y, Kuzushita N, et al. (2014). A case of non-cirrhotic portal hypertension associated with anti-retroviral therapy in a Japanese patient with human immunodeficiency virus infection. J Infect Chemother. (35 year old Japanese woman with HIV infection presented with ascites and gastrointestinal bleeding 4 years after stopping a 5 year course of didanosine [bilirubin 0.2 mg/dL, ALT 82 U/L, AST 83 U/L, Alk P 268 U/L, platelets 207,000 /µL, TE=9.3 kPa, biopsy showing no cirrhosis], with improvement and resolution of ascites and abnormal liver tests after control of bleeding and avoidance of nucleoside analogs).
Brescini L, Orsetti E, Gesuita R, Piraccini F, Marchionni E, Staffolani S, Castelli P, et al. (2014). Evaluating liver fibrosis by transient elastometry in patients with HIV-HCV coinfection and monoinfection. Hepat Mon. (Among 354 adults undergoing transient elastography (TE), abnormal stiffness was found in 13% with HIV infection alone, 39% with HCV infection alone and 51% with both; treatment with stavudine and didanosine being associated with higher TE scores).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, 5 of which [3%] were attributed to antiretroviral agents [nevirapine, zidovudine and lamivudine], but none to didanosine).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 12 cases [1.3%] were attributed to antiretroviral agents, including one to didanosine: a 44 year old woman with HIV infection who presented with ascites and was found to have noncirrhotic portal hypertension having been on didanosine and tenofovir for 6 years [bilirubin 0.5 mg/dL, ALT 94 U/L, Alk P 310 U/L]).
Gómez-Rubio J, Bárcena-Atalaya AB, Macías-García L, Lozano de León-Naranjo F. (2015). Med Clin (Barc). (42 year old woman with HIV infection presented with bleeding esophageal varices having been on didanosine for 6 years [bilirubin normal, ALT and Alk P elevated], liver biopsy showing nodular regenerative hyperplasia and liver tests improving after withdrawal of didanosine).
Turon F, Silva-Junior G, Hernandez-Gea V, Garcia-Pagan JC. (2015). Hipertensión portal idiopática no cirrótica. Gastroenterol Hepatol. (Review of noncirrhotic portal hypertension including epidemiology, pathogenesis, clinical presentation and management).
Arora A, Sarin SK. (2015). Multimodality imaging of obliterative portal venopathy: what every radiologist should know. Br J Radiol. (Review of the radiologic findings of noncirrhotic portal hypertension that accompanies obliterative portal venopathy; typical findings being increased spleen size and stiffness with normal or shrunken liver, portal vein enlargement and varices).
Stotts M, Chisholm P, Nurutdinova D, Maddur H. (2015). A case of non-cirrhotic portal hypertension associated with chronic didanosine therapy. ACG Case Rep J. (66 year old man with HIV on tenofovir, didanosine and nevirapine for many years developed weakness and abdominal distension and was found to have ascites and noncirrhotic portal hypertension [bilirubin 0.4 mg/dL, ALT 24 U/L, Alk P 157 U/L, HVPG 14]).
Gouvêa Ade F, Machado DM, Beltrão SC, Carmo FB, Mattar RH, Succi RC. (2015). Hipertensão portal não cirrótica em adolescente infectado pelo vírus da imunodeficiência humana (HIV). Rev Paul Pediatr. (13 year old boy with perinatally acquired HIV infection on long term tenofovir and didanosine was found to have enlargement of the liver and spleen [bilirubin not provided, ALT 36 U/L, Alk P 382 U/L, GGT 68 U/L, platelets 63,000/µL, TE 10 kPA, endoscopy small varices]; didanosine was stopped but no follow up given).
Ioannou GN, Bryson CL, Weiss NS, Boyko EJ. (2015). Associations between lipodystrophy or antiretroviral medications and cirrhosis in patients with HIV infection or HIV/HCV coinfection. Eur J Gastroenterol Hepatol. (In an analysis of the Veterans Administration Healthcare system Clinical Care Registry, long term use of didanosine but not other antiretroviral agents was found to be a risk factor for cirrhosis in patients with HIV monotherapy in contrast to patients with HIV-HCV coinfection, in whom all long term antiretroviral therapies were risk factors for cirrhosis).
Kovari H, Sabin CA, Ledergerber B, Ryom L, Reiss P, Law M, Pradier C, et al. (2016). Antiretroviral drugs and risk of chronic alanine aminotransferase elevation in human immunodeficiency virus (HIV)-monoinfected persons: the data collection on adverse events of anti-HIV drugs study. Open Forum Infect Dis. (Among 21,495 persons observed for an average of 4-5 years in a prospective observation study of adverse events among HIV positive patients without HBV or HCV on antiretroviral therapy, 6368 [30%] developed chronically elevated liver tests [6 per 100 patient years] and risk factors included didanosine, stavudine and tenofovir therapy but not lamivudine, abacavir or most protease inhibitors).
Vilarinho S, Sari S, Yilmaz G, Stiegler AL, Boggon TJ, Jain D, Akyol G, et al. (2016). Recurrent recessive mutation in deoxyguanosine kinase causes idiopathic noncirrhotic portal hypertension. Hepatology. (Complete exome sequencing of DNA from 8 children with idiopathic noncirrhotic portal hypertension identified an extremely rare gene variant which was homozygous in all 8 children, the gene being deoxyguanosine kinase, an enzyme required for mitochondrial DNA replication that is also inhibited by didanosine perhaps explaining its hepatotoxicity).
Ryom L, Lundgren JD, De Wit S, Kovari H, Reiss P, Law M, El-Sadr W, et al. (2016). D:A:D Study Group. Use of antiretroviral therapy and risk of end-stage liver disease and hepatocellular carcinoma in HIV-positive persons. AIDS. (Among 45,544 individuals followed for a median of 8.4 years in a prospective observation study of adverse events in patients with HIV infection on antiretroviral drugs, 209 developed end stage liver disease and 110 hepatocellular carcinoma, the combined rate being 1 per 1000 patient years; increased risk for these outcomes occurred in those with HCV and HBV infection, but was also linked to long term therapy with stavudine, didanosine, and tenofovir).
Scherpbier HJ, Terpstra V, Pajkrt D, Puthakanit T, Ananworanich J, Foster C, van den Bergh Weerman M, et al. (2016). Noncirrhotic portal hypertension in perinatally HIV-infected adolescents treated with didanosine-containing antiretroviral regimens in childhood. Pediatr Infect Dis J. (6 adolescents, ages 13 to 19 years, with neonatally acquired HIV infection presented with noncirrhotic portal hypertension, all six were female and all had received long term didanosine therapy [4-10 years; 4 also received stavudine 5-10 years]; in follow up of 1-6 years not receiving didanosine, all were stable, one required shunt to control variceal hemorrhage).
Logan S, Rodger A, Maynard-Smith L, O'Beirne J, Fernandez T, Ferro F, Smith C, et al. (2016). Prevalence of significant liver disease in human immunodeficiency virus-infected patients exposed to didanosine: a cross sectional study. World J Hepatol. (Among 99 patients with HIV infection who had received didanosine for at least 6 months who were screened for evidence of liver disease, 37% had abnormal ALT levels, 12% had abnormal TE scores [>7.65 kPa], and liver biopsy in 17 patients showed NRH in 2 [ages 43 and 59 years, ALT 77 and 36 U/L, Alk P 83 and 93 U/L, platelets 175,000/µL, HVPG 5 and 4 mm Hg]).
Gómez Alonso M, Goñi Esarte S, Bolado Concejo F, Urman Fernández JM, Basterra Ederra M, Kutz Leoz M, Zozaya Urmeneta JM. (2017). Idiopathic non-cirrhotic portal hypertension and portal vein thrombosis in a patient with HIV infection. Gastroenterol Hepatol. (39 year old man with HIV infection presented with variceal hemorrhage having been treated with didanosine for 3.5 years [bilirubin 0.8 mg/dL, ALT 25 U/L, Alk P 98 U/L, INR 1.0], with large varices on endoscopy, HVPG 10 mm Hg, TE 13.8 kPa, and biopsy showing nonspecific changes and scant fibrosis).
Gamero MT, Gallardo MS, Aguilar V, Bravo E, Guevara J, Mejia F. (2017). Hipertensión portal no cirrótica por didanosina. Un caso infrecuente. Rev Gastroenterol Peru. (39 year old HIV positive woman treated with didanosine, lamivudine and efavirenz for 5 years presented with ascites and portal hypertension, biopsy showing nodular regeneration and subsequently suffered with intractable ascites, recurrent upper gastrointestinal bleeding and died within the next year).
Figueiredo M, Nkuize M, Mulkay JP, De Wit S, Gomez M, Sersté T. (2017). Nodular Regenerative Hyperplasia in HIV-positive patients : a case series and review of the literature. Acta Gastroenterol Belg. (Clinical description of 3 HIV-positive patients [2 men, 1 woman, ages 33 to 52 years] who presented with noncirrhotic portal hypertension having been treated with didanosine for 4-11 years, liver histology demonstrating nodular regenerative hyperplasia).
Lee M, Izzy M, Akki A, Tanaka K, Kalia H. (2017). Nodular regenerative hyperplasia: a case of rare prognosis. J Investig Med High Impact Case Rep. (26 year old woman with perinatally acquired HIV infection developed splenomegaly and abnormal liver tests while on tenofovir, emtricitabine and atazanavir/ritonavir [bilirubin 0.7 mg/dL, ALT 83 U/L, AST 80 U/L, Alk P 260 U/L, platelets 72,000, INR 1.2, biopsy showing minimal fibrosis and nodular regeneration] who subsequently was found to have a hepatic mass on imaging suspected to be HCC; no mention of previous therapy with didanosine or stavudine).
Ahmad AK, Atzori S, Taylor-Robinson SD, Maurice JB, Cooke GS, Garvey L. (2019). Spleen stiffness measurements using point shear wave elastography detects noncirrhotic portal hypertension in human immunodeficiency virus. Medicine (Baltimore). (Among 25 patients with HIV infection undergoing shearwave elastography, spleen stiffness was more reliable than liver stiffness in assessing noncirrhotic portal hypertension, being elevated in 6 of 11 cases of NCPH but in none of 14 controls).

## OTHER REFERENCE LINKS

1 Recent References on Didanosine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Didanosine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Didanosine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Didanosine)